# Sonidegib

## OVERVIEW

### Introduction

Sonidegib is a small molecule kinase inhibitor that blocks signaling in the hedgehog pathway and is used in the therapy of unresectable or metastatic basal cell carcinoma. Sonidegib therapy is associated with a low rate or transient serum aminotransferase elevations during therapy, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Sonidegib (soe" ni deg' ib) is an orally available, kinase inhibitor with specific activity against a key step (activation of smoothened: SMO) in the hedgehog signaling pathway. Hedgehog is a key regulator of embryonic development, cell growth and differentiation. Mutations in this pathway have been identified in several malignant diseases including basal cell carcinoma. Clinical trials of sonidegib in patients with metastatic or locally advanced basal cell carcinoma have reported at least partial responses in up to 58% of patients. Sonidegib was approved for use in the United States in 2015, the second hedgehog pathway inhibitor approved for oral treatment of advanced basal cell carcinoma that is refractory or not amenable to treatment with surgery or radiation. Sonidegib is available in capsules of 200 mg under the brand name Odomzo. The recommended dose is 200 mg once daily until disease progression or unacceptable toxicity occurs. Side effects are frequent and often dose limiting although rarely life-threatening. Common side effects are similar to those reported with other inhibitors of the hedgehog signaling pathway and include muscle spasms, alopecia, anorexia, dysguesia, weight loss, nausea, diarrhea, fatigue, abdominal pain, headache, muscle and joint pains and serum creatine kinase (CK) elevations. Rare, but potentially severe adverse events include musculoskeletal adverse reactions and embryo-fetal toxicity.

### Hepatotoxicity

Most clinical trials of sonidegib included few patients and rates of liver tests abnormalities were often not reported. In isolated trials, serum ALT elevations were reported in 15% to 27% of patients and to rise above 5 times the upper limit of normal (ULN) in 1% to 6%. Rates of serum enzyme elevations were greater with higher doses, and all were apparently transient and resolved either spontaneously or with dose reductions or discontinuation. In these trials, there were no cases of clinically apparent liver injury, hepatitis with jaundice or death from liver failure. The product label for sonidegib mentions serum enzyme elevations as a possible adverse event, but does not mention liver injury with jaundice or hepatic failure. Since its approval and more widespread use, there have been no published cases of hepatotoxicity attributed to sonidegib, but it is an uncommonly used antineoplastic agent. Serum enzyme elevations were also rare with the initial hedgehog inhibitor, vismodegib, which has been implicated in causing at least one case of acute, self-limited cholestatic hepatitis (Case 1 in Vismodegib).

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum enzyme elevations during sonidegib therapy is unknown. Sonidegib is metabolized in the liver predominantly by CYP 3A and liver injury might be caused by a toxic or immunogenic metabolite. Alternatively, inhibition of the hedgehog pathway in hepatocytes may cause some degree of hepatic injury. Because sonidegib is a substrate for CYP 3A4, it is susceptible to drug-drug interactions with inducers or inhibitors of this microsomal enzyme.

### Outcome and Management

In using kinase inhibitors for treatment of cancer, serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) or any elevations accompanied by jaundice or symptoms should lead to dose reduction or temporary cessation. The various protein kinase inhibitors vary greatly in chemical structure and there is little evidence for cross sensitivity to the liver injury.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Related Drugs: Vismodegib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sonidegib – Odomzo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Sonidegib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Sonidegib | 956697-53-3 | C26-H26-F3-N3-O3 | Sonidegib structure

## ANNOTATED BIBLIOGRAPHY

References updated: 01 June 2017

Abbreviations used: CK, creatine kinase

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as sonidegib).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556-7. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not sonidegib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Pan S, Wu X, Jiang J, Gao W, Wan Y, Cheng D, Han D, et al. Discovery of NVP-LDE225, a potent and selective smoothened antagonist. ACS Med Chem Lett 2010; 1: 130-4. (In vitro demonstration of selective antagonism of the kinase receptor smoothened by a novel series of chemicals identified by high throughput screening for molecules that inhibited the hedgehog signaling pathway). 24900187
Tang JY, Mackay-Wiggan JM, Aszterbaum M, Yauch RL, Lindgren J, Chang K, Coppola C, et al. Inhibiting the hedgehog pathway in patients with the basal-cell nevus syndrome. N Engl J Med 2012; 366: 2180-8. (Among 41 patients with basal cell nevus syndrome, vismodegib therapy was associated with a lower rate of new tumors and decrease in size of existing tumors compared to placebo, but was associated with a high rate of side effects and 54% stopped therapy because of side effects; no mention of ALT elevations or hepatotoxicity). 22670904
Rodon J, Tawbi HA, Thomas AL, Stoller RG, Turtschi CP, Baselga J, Sarantopoulos J, et al. A phase I, multicenter, open-label, first-in-human, dose-escalation study of the oral smoothened inhibitor sonidegib (LDE225) in patients with advanced solid tumors. Clin Cancer Res 2014; 20: 1900-9. (Among 103 patients with different forms of advanced cancer treated with increasing doses of sonidegib, dose limiting toxicities were myalgia and increases in serum creatine kinase [CK] levels, while common side effects were muscle spasms, myalgia, gastrointestinal complaints, fatigue and alopecia, ALT elevations occurred in 15% of patients and were above 5 times ULN in 6%). 24523439
Migden MR, Guminski A, Gutzmer R, Dirix L, Lewis KD, Combemale P, Herd RM, et al. Treatment with two different doses of sonidegib in patients with locally advanced or metastatic basal cell carcinoma (BOLT): a multicentre, randomised, double-blind phase 2 trial. Lancet Oncol 2015; 16: 716-28. (Among 230 patients with advanced basal cell carcinoma treated with sonidegib [200 vs 800 mg daily] for a median of 14 months, objective response rates were similar for both doses [36% vs 34%], but adverse event rates were less with the lower dose, including muscle spasms [49% vs 69%] and ALT elevations [1% vs 4%]). 25981810
Minami H, Ando Y, Ma BB, Hsiang Lee J, Momota H, Fujiwara Y, Li L, et al. Phase I, multicenter, open-label, dose-escalation study of sonidegib in Asian patients with advanced solid tumors. Cancer Sci. 2016; 107: 1477-83. (Among 45 Asian adults with advanced cancer treated with increasing doses of sonidegib [400 to 800 mg daily], the most common adverse events were myalgia, fatigue and CK elevations while ALT elevations occurred in 27% and were above 5 times ULN in 14%). 27467121
Lacouture ME, Dréno B, Ascierto PA, Dummer R, Basset-Seguin N, Fife K, Ernst S, et al. Characterization and management of hedgehog pathway inhibitor-related adverse events in patients with advanced basal cell carcinoma. Oncologist 2016; 21: 1218-29. (Review of the adverse events caused by vismodegib and sonidegib including muscle spasms, gastrointestinal complaints and alopecia, but does not discuss ALT elevations or liver related events). 27511905
Dummer R, Guminski A, Gutzmer R, Dirix L, Lewis KD, Combemale P, Herd RM, et al. The 12-month analysis from Basal Cell Carcinoma Outcomes with LDE225 Treatment (BOLT): A phase II, randomized, double-blind study of sonidegib in patients with advanced basal cell carcinoma. J Am Acad Dermatol 2016; 75: 113-25.e5. (Among the 230 patients with advanced basal cell cancer enrolled in a clinical trial comparing 200 vs 800 mg doses of sonidegib [Migden 2015], 12 month objective response rates were 58% vs 44% and discontinuation rates for adverse events were 28% vs 37%, mostly for muscle spasms and CK elevations; no mention of ALT elevations or hepatotoxicity). 27067394
Jacobsen AA, Aldahan AS, Hughes OB, Shah VV, Strasswimmer J. Hedgehog pathway inhibitor therapy for locally advanced and metastatic basal cell carcinoma: a systematic review and pooled analysis of interventional studies. JAMA Dermatol 2016; 152: 816-24. (Systematic review of 11 publications on vismodegib and 2 on sonidegib as therapy for advanced basal cell carcinoma provides summary of efficacy outcomes and rates of side effects, but does not discuss ALT elevations or hepatotoxicity). 27096888
Danial C, Sarin KY, Oro AE, Chang AL. An investigator-initiated open-label trial of sonidegib in advanced basal cell carcinoma patients resistant to vismodegib. Clin Cancer Res 2016; 22: 1325-9. (Among 9 patients with advanced basal cell carcinoma who were resistant to vismodegib therapy and were treated with sonidegib, none had an objective response and side effects included muscle cramps, nausea and CK elevations; ALT levels were not mentioned). 26546616
Sonidegib (Odomzo) for basal cell carcinoma. Med Lett Drugs Ther 2016; 58 (1489): 31-2. (Concise review of the mechanism of action, efficacy, safety and costs of sonidegib shortly after its approval for use in the US; mentions the common side effects of muscle spasms, CK elevations, gastrointestinal complaints, fatigue and alopecia, but does not mention ALT elevations or hepatotoxicity). 26938701
Casey D, Demko S, Shord S, Zhao H, Chen H, He K, Putman A, et al. FDA approval summary: sonidegib for locally advanced basal cell carcinoma. Clin Cancer Res 2017; 23 (10): 2377-81. (Summary of result of the clinical trials that formed the basis of the FDA approval of sonidegib for advanced basal cell carcinoma discusses overall safety results and specific issues of musculoskeletal and embryo-fetal toxicities, but not ALT elevations or hepatotoxicity). 28073840

## OTHER REFERENCE LINKS

1. Recent References on Sonidegib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Sonidegib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Sonidegib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Sonidegib)